# Antiviral Agents

## OVERVIEW

The antivirals are a large and diverse group of agents that are typically classified by the virus infections for which they are used, their chemical structure and their mode of action. Most antiviral agents have been developed in the last 20 to 25 years, many as a result of the major research efforts to develop therapies and means of prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Some of the agents developed to treat HIV infection, AIDS and its complications were found to also inhibit other viruses, and the novel approaches taken in development of antiretroviral therapy have been applied to develop therapies of other viral infections.

Antiretroviral Agents for HIV Infection. The antiretroviral agents include nucleoside analogues with reverse transcriptase activity (such as tenofovir, emtricitabine, lamivudine, abacavir, stavudine, didanosine, zidovudine), the nonnucleoside reverse transcriptase inhibitors (such as delavirdine, efavirenz, etravirine, nevirapine and rilpivirine), protease inhibitors (atazanavir, darunavir, indinavir, ritonavir, tipranavir and many others), and miscellaneous agents such as maraviroc that inhibits binding of the HIV virus its T cell receptor (CCR5 coreceptor antagonist), enfuvirtide that blocks the uptake of HIV into cells (fusion inhibitor), and integrase inhibitors (raltegravir, elvitegravir and dolutegravir) that block the integrase enzyme of HIV.

Hepatitis B Agents. The agents active against hepatitis B virus (HBV) include several nucleoside analogues that are also active against and used to treat HIV infection (tenofovir, emtricitabine, lamivudine), as well as agents that are poorly if at all active against HIV (adefovir, entecavir and telbivudine). Alpha interferon and peginterferon (its long acting pegylated form) are also active against hepatitis B, but are no longer commonly used for this indication.

Hepatitis C Agents. The agents active against hepatitis C virus (HCV) include interferon alfa (1992) and peginterferon (2000) which are used in combination with ribavirin, a nucleoside analogue that potentiates the effects of interferon against hepatitis C by unclearly defined mechanisms. Progress in treatment of hepatitis C began to accelerate in 2010 with the introduction of the first direct acting anti-HCV agents, two HCV-specific protease inhibitors: boceprevir and telaprevir. While combinations of these protease inhibitors with peginterferon and ribavirin yielded high response rates (60% to 75%), the regimens were poorly tolerated, expensive and prolonged (courses were typically for 48 weeks). Beginning in 2013, new direct acting anti-HCV agents with potent activity against different regions of the virus were introduced, which in combination obviated the need for interferon and yielded sustained response rates of greater than 90% with 12 to 24 weeks of treatment. The direct acting agents were directed against 3 components of HCV: HCV protease (NS3) inhibitors included simeprevir [2013], paritaprevir [2015], grazoprevir [2016] and glecaprevir [2017]); HCV RNA polymerase (NS5B) inhibitors included sofosbuvir [2013, a nucleoside analogue] and dasabuvir [2015, a non-nucleoside inhibitor]; and, HCV NS5A inhibitors included daclatasvir [2015], elbasvir [2016], lepidasvir [2014], ombitasvir [2015], velpatsvir [2016] and pibrentasvor [2017]. Combinations of 2 or 3 of these achieve sustained response rates of greater than 90%, with relatively short courses of therapy (8, 12 to 16 weeks) and without the need of interferon and its difficult and dose-limiting side effects. These combinations are available under brand names such as Harvoni, Technive, Viekira Pak, Zepatier, Epclusa and Mavyret. Newer agents and different combination products are likely to be developed in the future. Many of the earlier combinations are likely to be discontinued as newer regimens are more effective, better tolerated and active against all genotypes and in patients with renal disease, HIV infection or cirrhosis.

Herpes Virus Agents. The agents active against various herpes viruses (herpes simplex, varicella zoster, cytomegalovirus) include acyclovir and related acyclic nucleoside analogues such as valacyclovir, cidofovir, famciclovir, ganciclovir and valganciclovir, and other miscellaneous agents such as foscarnet.

Influenza Agents. The agents active against influenza A virus include amantadine and rimantadine which act on viral uncapping, three neuraminidase inhibitors oseltamivir (oral), zanamivir (by inhalation) and peramivir (intravenous), and most recently a cap-dependent endonuclease inhibitor baloxavir (oral). These agents are used during influenza outbreaks, generally for a brief period only, but are effective in prevention as well as amelioration of influenza infection.

COVID-19 Agents. The agents active against SARS-CoV-2, the cause of the epidemic of novel coronavirus infections) were developed rapidly during the pandemic of this disease that started in 2019 (COVID-19). The agents developed include remdesivir, molnupiravir, and Paxlovid (nirmatrelvir and ritonavir) and several monoclonal antibodies. Their major use is in treating patients with early symptoms of COVID-19 where they have been shown to ameliorate the clinical disease and outcome of infection; their efficacy in advanced cases with respiratory failure is less clear.

Orthopox Virus Agents. Several agents active against smallpox (variola) infection were developed as a part of biologic defense initiative against possible bioterrorism using smallpox virus. Tecovirimat was approved for this use in 2018 and brincidofovir in 2021, both under the Animal Rule protocol based upon efficacy studies in animal models and safety studies in health volunteers or subjects with another type of viral infection. These agents saw emergency usefulness during the outbreaks of mpox (formerly named monkeypox) virus infection in 2022 as they both had activity against mpox virus in cell culture and in animal models of similar orthopox viruses.

The following drug records are discussed individually.

### Drugs for HIV Infection, in the Subclass Antiretroviral Agents

- Attachment Inhibitors (HIV)
  - Fostemsavir
- Capsid Inhibitor
  - Lenacapavir
- Fusion Inhibitors (HIV)
  - Enfuvirtide, Maraviroc
- Integrase Inhibitors (HIV)
  - Bictegravir, Cabotegravir, Dolutegravir, Elvitegravir, Raltegravir
- Monoclonal Antibodies
  - Ibalizumab
- Nonnucleoside Reverse Transcriptase Inhibitors (HIV)
  - Delavirdine, Doravirine, Efavirenz, Etravirine, Nevirapine, Rilpivirine
- Nucleoside Analogues (HIV)
  - Abacavir, Didanosine, Emtricitabine, Lamivudine, Remdesivir, Stavudine, Tenofovir, Zidovudine
- Protease Inhibitors (HIV)
  - Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

### Drugs for Hepatitis B

- Alpha Interferon, Adefovir, Emtricitabine, Entecavir, Lamivudine, Telbivudine, Tenofovir

### Drugs for Hepatitis C

- Interferon Based Therapies
  - Alpha Interferon and Peginterferon, Ribavirin
- HCV NS5A Inhibitors
  - Daclatasvir, Elbasvir, Ledipasvir, Ombitasvir, Pibrentasvir, Velpatasvir
- HCV NS5B (Polymerase) Inhibitors
  - Dasabuvir, Sofosbuvir
- HCV Protease Inhibitors
  - Asunaprevir, Boceprevir, Glecaprevir, Grazoprevir, Paritaprevir, Simeprevir, Telaprevir, Voxilaprevir
- Combination Therapies
  - Epclusa, Harvoni, Mavyret, Technive, Viekira Pak, Vosevi, Zepatier

### Drugs for Herpes Virus Infections (HSV, CMV, others)

- Acyclovir, Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Maribavir, Valacyclovir, Valganciclovir

### Drugs for Influenza

- Amantadine, Baloxavir, Oseltamivir, Peramivir, Rimantadine, Zanamivir

### Drugs for COVID-19

- Molnupiravir
- Paxlovid
- Remdesivir
- Monoclonal Antibodies to SARS-CoV-2

### Drugs for Orthopox Viruses (Smallpox, Mpox)

- Brincidofovir
- Tecovirimat

## ANNOTATED BIBLIOGRAPHY

References updated: 18 October 2022

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents; mentions that risk of liver injury with different protease inhibitors is controversial, but that tipranavir, darunavir, lopinarivr and ritonavir are the leading causes in most case reports and reviews on the topic).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
NIH. https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
AASLD. https://www.hcvguidelines.org/ (Clinical guidelines on the diagnosis, management and therapy of hepatitis C from the American Association for the Study of Liver Diseases and the Infectious Diseases Society of America, with regular updates).
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of safety and efficacy of antiviral agents). 23459414
Antiviral drugs for influenza 2013-2014. Med Lett Drugs Ther 2014; 56 (1434): 6-8. (Concise summary of safety and efficacy of medications for influenza appropriate for the 2013-14 season mentions that adverse effects of oseltamivir include nausea, vomiting and headache; no mention of liver injury). 24457560
European Association for Study of Liver. EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol 2015; 63: 199-236. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver clinical, academic and research society). 25911336
AASLD/IDSA HCV Guidance Panel. Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology 2015; 62: 932-54. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies). 26111063
Antiviral drugs for seasonal influenza 2016-2017. Med Lett Drugs Ther 2017; 59 (1511): 1-3. (Concise summary of safety and efficacy of medications for influenza appropriate for the 2016-17 season; discusses side effects of oseltamivir and zanamivir, but does not mention ALT elevations or hepatotoxicity). 28026833
Antiviral drugs for varicella-zoster virus and herpes simplex virus infections. Med Lett Drugs Ther. 2018;60(1556):153-157. (Concise summary of safety and efficacy of medications for herpes simplex and varicella-zoster; discusses side effects of acyclovir [oral and intravenous], valacyclovir, and famciclovir without mentioning ALT elevations or hepatotoxicity). 30383727
Antiviral drugs for influenza. Med Lett Drugs Ther. 2020;62(1589):1-4. (Concise summary of safety and efficacy of medications for influenza appropriate for the 2020-21 season; discusses adverse side effects of oral oseltamivir, intravenous peramivir, inhaled zanamivir and oral baloxavir without mention of ALT elevations or hepatotoxicity). 31999661
Prevention and treatment of monkeypox. Med Lett Drugs Ther. 2022;64(1658):137-139. (Concise review on the global outbreak of mpox disease in 2022 that was associated with human-to-human transmission, most frequently in men who have sex with men, and a summary of prevention [vaccination with ACAM2000 or Jynneos, which are live vaccinia virus vaccines approved for prevention of smallpox], and treatment [two agents that are approved as therapy of smallpox which are available under an expanded access protocol for mpox]). 36094551